# Finerenone

## OVERVIEW

### Introduction

Finerenone is a selective, nonsteroidal mineralocorticoid receptor antagonist that is used in the therapy of chronic renal disease in patients with type 2 diabetes to slow progression of renal dysfunction and reduce the risk of cardiovascular disease morbidity and mortality. Finerenone has not been linked to serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Finerenone (fin er’ e none) is a selective, nonsteroidal mineralocorticoid receptor antagonist that is used to treat chronic renal disease in patients with type 2 diabetes. Patients with chronic renal disease have high levels of serum aldosterone, a mineralocorticoid hormone that, upon engagement of its cellular receptors in the kidney, leads to sodium retention and loss of potassium. Aldosterone activation also appears to increase proinflammatory cytokines and mediators of fibrosis in kidneys and elsewhere. The finding of elevation in aldosterone levels in patients with renal disease led to strategies to reduce mineralocorticoid receptor activation in patients with chronic kidney disease. In several randomized, placebo controlled trials, chronic therapy with finerenone, a specific inhibitor of the mineralocorticoid receptor, was shown to decrease albuminuria, prevent decline in estimated glomerular filtration rate (eGFR), and decrease renal as well as cardiovascular death in patients with chronic kidney disease and type 2 diabetes. Finerenone was approved for this indication in the United States in 2021. Finerenone is available as tablets of 10 and 20 mg under the brand name Kerendia. The recommended maintenance dose is 20 mg daily after a 4 week titration phase. Finerenone is contraindicated in patients with renal failure (eGFR less than 20 mL/min) and in patients with hyperkalemia. It is typically used in combination with either an angiotensin-converting enzyme (ACE) inhibitor or an angiotensin II receptor blocker (ARB). Side effects of finerenone can include hyperkalemia, hyponatremia and hypotension. Severe hyperkalemia can occur with finerenone therapy in patients with renal failure, with preexisting hyperkalemia, and in those taking potent inducers of CYP 3A4.

### Hepatotoxicity

In placebo-controlled trials of finerenone in several thousand patients, there was usually no mention of serum enzyme elevations or hepatotoxicity. In the largest placebo controlled trial, the rate of “hepatobiliary” adverse events was similar in patients on finerenone compared to placebo (4.4% vs 4.8%), and there were no reported hepatic serious adverse events. Since its approval and more widespread use, finerenone has not been implicated in instances of acute hepatic injury and the product label does not mention aminotransferase elevations or clinically apparent liver injury in lists of potential adverse events.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which finerenone might cause liver injury is not known. Finerenone is metabolized in the liver largely via the cytochrome P450 system. It is a substrate of CYP 3A4 and it should be avoided in patients taking inhibitors or inducers of CYP 3A4. In particular, potent inhibitors of CYP 3A4 can cause increases in plasma levels of finerenone which can trigger its dose-dependent side effects such as hyperkalemia and hyponatremia.

Drug Class: Cardiovascular Agents

Other Drugs for Renal Disease: Eplerenone, Spironolactone, SGLT2 Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES; Finerenone – Kerendia®; DRUG CLASS; Cardiovascular Agents; COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Finerenone); Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Finerenone | 1050477-31-0 | C21-H22-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2023

Abbreviations: ACE, angiotensin converting enzyme; ARB, angiotensin receptor blocker; eGFR, estimated glomerular filtration rate; SGLT2, sodium-glucose cotransporter 2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of finerenone mentions that thiazide diuretics have been implicated in rare instances of hepatotoxicity but does not discuss spironolactone or finerenone).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215341Orig1s000IntegratedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA integrated review of the finerenone application for safety and efficacy which mentions [page 54] that laboratory findings other than those of electrolytes and creatinine “did not reveal any other findings of interest or concern”).
Pitt B, Kober L, Ponikowski P, Gheorghiade M, Filippatos G, Krum H, Nowack C, et al. Safety and tolerability of the novel non-steroidal mineralocorticoid receptor antagonist BAY 94-8862 in patients with chronic heart failure and mild or moderate chronic kidney disease: a randomized, double-blind trial. Eur Heart J. 2013; 34: 2453-63. (Among 457 patients with chronic renal disease treated with different doses of finerenone [2.5, 5 or 10 mg daily], spironolactone or placebo for 4 weeks, there was less hyperkalemia with finerenone than spironolactone and adverse events were generally mild; no mention of ALT elevations or hepatotoxicity). 23713082
Bakris GL, Agarwal R, Chan JC, Cooper ME, Gansevoort RT, Haller H, Remuzzi G, et al.; Mineralocorticoid Receptor Antagonist Tolerability Study–Diabetic Nephropathy (ARTS-DN) Study Group. Effect of finerenone on albuminuria in patients with diabetic nephropathy: A randomized clinical trial. JAMA. 2015; 314: 884-94. (Among 821 patients with diabetes and albuminuria treated with 7 different doses of finerenone [1.25 to 25 mg daily] or spironolactone or placebo for 4 weeks, there was a dose-dependent decrease in urinary albumin while hyperkalemia arose with higher doses of finerenone; no mention of ALT levels or hepatotoxicity). 26325557
Filippatos G, Anker SD, Böhm M, Gheorghiade M, Køber L, Krum H, Maggioni AP, et al. A randomized controlled study of finerenone vs. eplerenone in patients with worsening chronic heart failure and diabetes mellitus and/or chronic kidney disease. Eur Heart J. 2016; 37: 2105-14. (Among 821 adults with diabetes and albuminuria treated with one of 7 different doses of finerenone [1.25 to 25 mg] or placebo once daily for 90 days, there was a dose-dependent reduction in urinary albumin levels in finerenone treated patients and an increased rate of hyperkalemia with the higher doses; no mention of ALT levels or hepatotoxicity). 27130705
Bakris GL, Agarwal R, Anker SD, Pitt B, Ruilope LM, Rossing P, Kolkhof P, et al.; FIDELIO-DKD Investigators. Effect of finerenone on chronic kidney disease outcomes in type 2 diabetes. N Engl J Med. 2020; 383: 2219-2229. (Among 5674 patients with chronic kidney disease and type 2 diabetes treated with finerenone [20 mg daily] or placebo for a median of 2.6 years, finerenone was associated with lower rates of a combined endpoint of renal failure, a decrease in eGFR [40%] and lower rates of renal death [18% vs 21%], but no difference in overall mortality or hospitalization, while adverse event rates were similar in the two groups including those classified as “hepatobiliary” [4.4% vs 4.8%], while discontinuations because of hyperkalemia occurred in 2.3% vs 0.9%). 33264825
Ingelfinger JR, Rosen CJ. Finerenone–halting relative hyperaldosteronism in chronic kidney disease. N Engl J Med. 2020; 383: 2285-2286. (Editorial in response to Bakris [2020] discusses the role of aldosterone activation in causing sodium retention but also release of mediators of inflammation and fibrosis, which has led to strategies to decrease aldosterone activation as therapy of chronic renal disease). 33095527
Allison SJ. Finerenone in chronic kidney disease. Nat Rev Nephrol. 2021; 17: 13. (Commentary on the results of treating patients with chronic kidney disease with long term finerenone [Bakris 2020] and role of aldosterone activation in causing inflammation and fibrosis leading to progression of renal and heart disease, mentions that an ongoing trial will assess the effects of finerenone on patients with less advanced chronic renal disease). 33110253
Heinig R, Gerisch M, Engelen A, Nagelschmitz J, Loewen S. Pharmacokinetics of the novel, selective, non-steroidal mineralocorticoid receptor antagonist finerenone in healthy volunteers: results from an absolute bioavailability study and drug-drug interaction studies in vitro and in vivo. Eur J Drug Metab Pharmacokinet. 2018;43:715-727. (Evaluation of pharmacokinetics of finerenone in health volunteers found that it was metabolized mostly by CYP 3A4 and to a lesser extent by CYP 2C8, but only CYP 3A4 inducers and inhibitors had an effect on finerenone levels). 29779093
Agarwal R, Filippatos G, Pitt B, Anker SD, Rossing P, Joseph A, Kolkhof P, et al.; FIDELIO-DKD and FIGARO-DKD investigators. Cardiovascular and kidney outcomes with finerenone in patients with type 2 diabetes and chronic kidney disease: the FIDELITY pooled analysis. Eur Heart J. 2022;43:474-484. (Pooled analysis of two randomized controlled trials of finerenone [10 or 20 mg] versus placebo in patients with type 2 diabetes and chronic renal disease in 13,026 adults with median follow up of 3 years found lower rates of composite endpoints of cardiovascular events and worsening renal function with finerenone therapy [12.7% vs 14.4%], with similar adverse event rates [86.1% vs 86.4%] but higher rates of hyperkalemia [12% vs 6%]; no mention of ALT elevations or hepatotoxicity). 35023547
Finerenone (Kerendia) for chronic kidney disease. Med Lett Drugs Ther. 2021;63:131-132. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of finerenone shortly after its approval in the US, mentions adverse events of hyperkalemia, hyponatremia, and hypotension; no mention of ALT elevations or hepatotoxicity). 34544101
Rossing P, Anker SD, Filippatos G, Pitt B, Ruilope LM, Birkenfeld AL, McGill JB, et al.; FIDELIO-DKD and FIGARO-DKD Investigators. Finerenone in patients with chronic kidney disease and type 2 diabetes by sodium-glucose cotransporter 2 inhibitor treatment: The FIDELITY Analysis. Diabetes Care. 2022;45:2991-2998. (Re-analysis of trials of finerenone in patients with chronic renal disease and diabetes showed that it was effective in the subgroup of patients receiving SGLT2 inhibitors with no difference in tolerance). 35972218
In brief: Finerenone (Kerendia) for diabetic kidney disease. Med Lett Drugs Ther. 2023;65:15-16. (Brief summary of the mechanism of action, clinical efficacy and safety of finerenone shortly after published guidelines on its use were published, mentions that finerenone has been shown to modestly improve renal and cardiovascular outcomes, but it is expensive and can cause hyperkalemia). 36651794
Perakakis N, Bornstein SR, Birkenfeld AL, Linkermann A, Demir M, Anker SD, Filippatos G, et al.; FIDELIO-DKD and FIGARO-DKD investigators. Efficacy of finerenone in patients with type 2 diabetes, chronic kidney disease and altered markers of liver steatosis and fibrosis: A FIDELITY subgroup analysis. Diabetes Obes Metab. 2023 Oct 10. Epub ahead of print. (Re-analysis of trials of finerenone in patients with chronic renal disease and diabetes focusing upon the subgroup of patients with evidence of concurrent nonalcoholic fatty liver disease found similar efficacy and safety as in patients without evidence of liver abnormalities and that liver tests did not worsen with treatment).

## OTHER REFERENCE LINKS

Recent References on Finerenone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Finerenone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Finerenone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Finerenone)